# Pirtobrutinib

## OVERVIEW

### Introduction

Pirtobrutinib is an orally available small molecule inhibitor of Bruton tyrosine kinase that is used to treat chronic lymphocytic leukemia and lymphomas. Pirtobrutinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy but has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Pirtobrutinib (pir” toe broo’ tin ib) is an orally available, specific inhibitor of Bruton tyrosine kinase, an important signaling molecule in B cell activation and proliferation that is used to treat chronic lymphocytic leukemia and several forms of B cell related lymphomas. The inhibition of Bruton tyrosine kinase down regulates the activation and proliferation of malignant B cells. Pirtobrutinib was shown to have activity in animal models of lymphoma and chronic lymphocytic leukemia. In an open label trial of pirtobrutinib in adult patients with relapsed or refractory B cell related malignancies, the overall objective response rate in those with mantle cell lymphoma was 50%, and 13% of patients had a complete response. The median duration of response was 8 months. Based upon these results, pirtobrutinib was given accelerated approval as therapy for adults with relapsed or refractory mantle cell lymphoma after at least two lines of systemic therapy, including a bruton tyrosine kinase inhibitor (such as ibrutinib or acalabrutinib). Subsequently, indications were expanded to include adults with chronic lymphocytic leukemia or small cell lymphoma who had received at least two prior lines of therapy, including both a Bruton tyrosine kinase and a B cell lymphoma 2 (BCL-2) inhibitor. Pirtobrutinib is available in tablets of 50 and 100 mg under the brand name Jaypirca. The recommended dose is 200 mg orally once daily with reductions for renal impairment and for managing toxicity. Common adverse events include fatigue, musculoskeletal pain, diarrhea, bruising, cough, and infections. Laboratory abnormalities include reductions in neutrophil, lymphocyte, platelet counts and hemoglobin. Potential severe adverse events include febrile neutropenia, severe infections, hemorrhage, cardiac arrythmias, hepatotoxicity, second primary malignancies, and embryo-fetal toxicity.

### Hepatotoxicity

In the open label prelicensure clinical trials of pirtobrutinib in patients with various B cell related malignancies serum aminotransferase elevations occurred in up to 23% of pirtobrutinib treated subjects. The elevations were typically mild and transient, but 2% to 3% of patients developed values above 5 times the upper limit of normal (ULN). The elevations occasionally led to temporary discontinuations, but more often resolved even without dose adjustment. In prelicensure studies, there were no instances of acute liver injury with symptoms or jaundice attributed to pirtobrutinib. Since approval and more widescale availability of pirtobrutinib, there have been no published reports of hepatotoxicity associated with its use. However, drug induced liver injury including acute liver failure and deaths have been reported with other Bruton tyrosine kinase inhibitors (mainly with ibrutinib) and several have been linked to instances of reactivation of hepatitis B which can be fatal.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury as well as reactivation of chronic hepatitis B).

### Mechanism of Injury

The cause of mild serum enzyme elevations during pirtobrutinib therapy is not known. Because it affects B cell maturation and proliferation, pirtobrutinib may reactivate latent infections such as hepatitis B, herpes zoster, or tuberculosis. Pirtobrutinib is metabolized in the liver predominantly by cytochrome P450 CYP 3A4 and serum levels are affected by agents that inhibit or induce this microsomal drug metabolizing enzyme.

### Outcome and Management

Monitoring of serum aminotransferase levels is recommended for patients starting pirtobrutinib based largely on experience with other Bruton tyrosine kinase inhibitors such as ibrutinib. De novo elevations in serum aminotransferases levels above 5 times the upper limit of normal should lead to at least temporary cessation. If no other cause of the serum enzyme elevations is identified, or if they do not resolve or improve within a few weeks, or if symptoms of liver injury or jaundice arise, pirtobrutinib should be discontinued. Because of the risk of hepatitis B virus (HBV) reactivation by Bruton tyrosine kinase inhibitors, screening for HBV markers (HBsAg and anti-HBc) before starting therapy is appropriate. In patients with evidence of ongoing (HBsAg) or previous (anti-HBc) HBV infection, either prophylaxis or careful monitoring should be considered. There does not appear to be cross reactivity in risk for hepatic injury between pirtobrutinib and other Bruton kinase inhibitors or other biologic or non-biologic therapies for chronic lymphocytic leukemia or lymphoma.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Bruton Tyrosine Kinase Inhibitors: Acalabrutinib, Ibrutinib, Zanubrutinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pirtobrutinib – Jaypirca®

DRUG CLASS

Protein Kinase Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Pirtobrutinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pirtobrutinib | 2101700-15-4 | C22-H21-F4-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 15 July 2024

Abbreviations used: GvHD, graft-vs-host disease; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as pirtobrutinib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not the Bruton tyrosine kinase inhibitors such as ibrutinib and pirtobrutinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; discusses ibrutinib but not acalabrutinib, zanubrutinib, or pirtobrutinib).
FDA. Integrated Review. 2021. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216059Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application of pirtobrutinib for safety and efficacy, mentions that in a pooled safety cohort of 583 treated subjects, treatment emergent ALT elevations arose in 15% which were above 5 times ULN in 2%, but there were no instances of ALT elevations with jaundice attributed to pirtobrutinib, concluding that “Safety data…did not identify any risk of drug-induced liver injury…”).
Mato AR, Shah NN, Jurczak W, Cheah CY, Pagel JM, Woyach JA, Fakhri B, et al. Pirtobrutinib in relapsed or refractory B-cell malignancies (BRUIN): a phase 1/2 study. Lancet. 2021;397(10277): 892-901. (Among 323 patients with previously treated B cell malignancies treated with 7 different doses of pirtobrutinib, no dose limiting toxicity was found and 200 mg daily was chosen for evaluation of efficacy which yielded an overall response rate of 52% in 56 patients with mantle cell lymphoma, 63% in 139 with chronic lymphocytic leukemia, and 68% in 19 with Waldenström macroglobulinemia; while adverse events in the safety population included fatigue in 20%, diarrhea 17%, bruising 13%, neutropenia 13%, nausea 9%, and headache 9%, with only 1% requiring permanent discontinuation; no mention of hepatotoxicity or ALT elevations). 33676628
Michot JM, Ribrag V. Pirtobrutinib shows evidence to inaugurate a third generation of BTK inhibitors. Lancet. 2021;397(10277):855-857. (Editorial in response to Mato [2021] mentions that pirtobrutinib is a 3rd generation Bruton tyrosine kinase inhibitor that has greater selectivity, lack of cross resistance, and perhaps fewer off-target adverse events than ibrutinib [1st generation] as well as acalabrutinib and zanubrutinib [2nd generation] all of which bind covalently with the C481 kinase binding site while pirtobrutinib binds non-covalently [reversibly] to different site). 33676615
Wang E, Mi X, Thompson MC, Montoya S, Notti RQ, Afaghani J, Durham BH, Penson A, et al. Mechanisms of resistance to noncovalent Bruton's tyrosine kinase inhibitors. N Engl J Med. 2022;386(8):735-743. (Among 55 patients with chronic lymphocytic leukemia who developed resistance to pirtobrutinib, all had mutations in the catalytic domain of Bruton tyrosine kinase [not in the C481 binding site of the kinase], and some of these mutations also conferred resistance to covalent inhibitors such as ibrutinib). 35196427
Perutelli F, Montalbano MC, Boccellato E, Coscia M, Vitale C. Beyond ibrutinib: novel BTK inhibitors for the treatment of chronic lymphocytic leukemia. Curr Opin Oncol. 2022;34(6):757-767. (Review of the FDA approved Bruton tyrosine kinase inhibitors including the non-covalently and reversibly binding 3^rd^ generation pirtobrutinib as well as several agents in development; no discussion of hepatotoxicity). 35993294
Eyre TA, Shah NN, Dreyling M, Jurczak W, Wang Y, Cheah CY, Song Y, et al. BRUIN MCL-321: phase III study of pirtobrutinib versus investigator choice of BTK inhibitor in BTK inhibitor naïve mantle cell lymphoma. Future Oncol. 2022;18:3961-3969. (Description of a planned trial comparing pirtobrutinib vs other Bruton kinase inhibitors in subjects with mantle cell lymphoma not previously treated with a Bruton tyrosine kinase inhibitor). 36377973

## OTHER REFERENCE LINKS

1. Recent References on Pirtobrutinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pirtobrutinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Pirtobrutinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pirtobrutinib)